# Riluzole

## OVERVIEW

### Introduction

Riluzole is a neuroprotective agent used for therapy of amyotrophic lateral sclerosis. Riluzole is associated with a low rate of serum aminotransferase elevations during therapy and has been linked to rare instances of clinically apparent, acute liver injury.

### Background

Riluzole (ril' ue zole) is a benzothiazole that is neuroprotective in vitro and in vivo. The mechanism by which it protects neurons from toxic injury is unknown, but it appears to inhibit glutamate release, to block post-synaptic glutamate receptors and to inactivate voltage dependent sodium channels. Studies in patients with amyotrophic lateral sclerosis suggest that riluzole may slow disease progression and neurologic deterioration. Riluzole was approved for use in the United States in 1995 and is commonly used in management of amyotrophic lateral sclerosis. Riluzole is available in tablets of 50 mg under the brand name Rilutek. The typical maintenance dosage is 50 mg every 12 hours. Common side effects include fatigue, weakness, dizziness, nausea, diarrhea, and cough.

### Hepatotoxicity

Serum aminotransferase elevations occur in approximately up to 12% of patients on long term riluzole therapy, but elevations above 3 times the upper limit of normal (ULN) occur in less than 3% of patients. These elevations are usually mild-to-moderate in severity and are rarely associated with symptoms. Most elevations resolve spontaneously, but persistent or marked elevations require drug discontinuation or dose modification. Routine monitoring of serum aminotransferase levels is recommended for the first 6 months of therapy. Clinically apparent liver injury due to riluzole is rare, but several cases have been reported, arising after 1 to 12 months of therapy and characterized by a hepatocellular or mixed pattern of serum enzyme elevations. Immunoallergic and autoimmune features were uncommon. Most cases were mild to moderate in severity and recovery was rapid upon drug discontinuation, but evidently fatal cases have been reported to the sponsor.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Riluzole is extensively metabolized by the liver by the cytochrome P450 system into multiple intermediates, not all of which have been characterized. The hepatotoxicity of riluzole may be related to production of a toxic or immunogenic intermediate.

### Outcome and Management

The severity of liver injury from riluzole ranges from minor, transient elevations in serum aminotransferase levels to acute hepatic injury with jaundice and possible to acute liver failure. Routine monitoring of serum aminotransferase levels is recommended during the first 6 months of riluzole therapy and therapy discontinued for elevations greater than 5 times ULN. Riluzole has not been linked to cases of chronic hepatitis or vanishing bile duct syndrome. Restarting riluzole can result in recurrence of liver injury and should be avoided.

Drug Class: Alzheimer Disease Agents, Amyotrophic Lateral Sclerosis Agents

Other Related Drugs: Edaravone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Riluzole – Rilutek®

DRUG CLASS

Amyotrophic Lateral Sclerosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Riluzole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Riluzole | 1744-22-5 | C8-H5-F3-N2-O-S | Riluzole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 28 May 2018

Zimmerman HJ. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 709-42. (Expert review of hepatotoxicity published in 1999; riluzole is mentioned for its potential to cause ALT elevations [~6%]).
Larrey D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 518. (Review of hepatotoxicity of psychotropic agents published in 2007; mentions that serum ALT elevations occur in up to 12% of patients on riluzole, but that clinically apparent liver injury is rare, only 5 cases having been reported in the literature).
Standaert DG, Roberson ED. Amyotrophic lateral sclerosis (ALT). Treatment of central nervous system degenerative disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 624-6. (Textbook of pharmacology and therapeutics). .
Castells LI, Gamez J, Cervera C, Guardia J. Icteric toxic hepatitis associated with riluzole. Lancet 1998; 351: 648. (71 year old woman developed jaundice 6 months after starting riluzole for amyotrophic lateral sclerosis [bilirubin 15.4 mg/dL, ALT 1026 U/L, Alk P 356 U/L], with rapid resolution and normal values within 2 months of stopping). 9500328
Remy A-J, Camu W, Ramos J, Blanc P, Larrey D. Acute hepatitis after riluzole administration. J Hepatol 1999; 30: 527-30. (Two women with amylotrophic lateral sclerosis, ages 56 and 71, developed evidence of liver injury 7 and 4 weeks after starting riluzole [bilirubin normal and 4.5 mg/dL, ALT 22 and 3 times ULN, Alk P normal], with resolution in 4-12 weeks, one patient had positive rechallenge). 10190739
Barbare JC, Imbert A, Benkirane A. [Recent developments concerning drug- induced liver toxicity]. Presse Med 2001; 30: 673-6. French. (Review of importance of central reporting of drug induced liver injury, providing examples of recently described hepatotoxic reactions, including 3 recent cases of hepatocellular injury due to riluzole). 11360729
Jankovic J, Hunter C. A double-blind, placebo-controlled and longitudinal study of riluzole in early Parkinson's disease. Parkinsonism Relat Disord 2002; 8: 271-6. (Among 20 patients with early Parkinson disease treated with riluzole or placebo for 12 months, none developed any abnormality in liver tests and their were no discontinuations or serious adverse events due to liver injury). 12039422
Miller RG, Mitchell JD, Lyon M, Moore DH. Riluzole for amyotrophic lateral sclerosis (ALS)/motor neuron disease (MND). Amyotroph Lateral Scler Other Motor Neuron Disord 2003; 4: 191-206. (Systematic review of safety and efficacy of riluzole identified 4 controlled trials; ALT elevations >3 times ULN were 2.6 times more frequent in riluzole than placebo treated subjects). 13129806
Bensimon G, Doble A. The tolerability of riluzole in the treatment of patients with amyotrophic lateral sclerosis. Expert Opin Drug Saf 2004; 3: 525-34. (Review of pharmacology, efficacy and safety of riluzole in amyotrophic lateral sclerosis; ALT elevations >3 times ULN occurred in 35 [9%] of 395 patients on riluzole vs 12 of 406 [3%] on placebo; all resolved either despite continuing or with stopping: recommended monthly monitoring of aminotransferase levels for first 3 months of treatment). 15500412
Henderson RD, McCombe PA. Riluzole: a glimmer of hope in the treatment of motor neurone disease. Med J Aust 2005; 183: 164; author reply 164-5. (Man in his 50s with motor neurone disease developed jaundice 11 months after starting riluzole and 3 months after starting naltrexone [bilirubin not reported, ALT 3030 U/L], resolving "gradually" after stopping both drugs). 16053424
Wokke J. Riluzole. Lancet 1996; 348 (9030): 795-9. (Review of structure, mechanisms of action, pharmacokinetics, efficacy and safety of riluzole; mentions that ALT and AST elevations occur not infrequently, but are usually less than 3 times ULN and that no case of jaundice has been reported). 8813989
Zoing MC, Burke D, Pamphlett R, Kiernan MC. Riluzole therapy for motor neurone disease: an early Australian experience (1996-2002). J Clin Neurosci 2006;13:78-83. (Among 25 patients with motor neurone disease treated with riluzole for up to 12 months, "there was no significant alteration" in ALT or AST). 16410201
Landwehrmeyer GB, Dubois B, de Yébenes JG, Kremer B, Gaus W, Kraus PH, Przuntek H, et al; European Huntington's Disease Initiative Study Group. Riluzole in Huntington's disease: a 3-year, randomized controlled study. Ann Neurol 2007; 62: 262-72. (Among 537 adults with Huntington disease treated with riluzole or placebo for up to 3 years, 7 [2%] on riluzole and 1 [0.5%] on placebo had ALT elevations and 5 patients on riluzole stopped therapy because of liver enzyme elevations; no mention of clinically apparent liver injury or serious hepatic adverse events). 17702031
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to riluzole). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to riluzole). 20949552
Grossman RG, Fehlings MG, Frankowski RF, Burau KD, Chow DS, Tator C, Teng A, et al. A Prospective, Multicenter, Phase I Matched-Comparison Group Trial of Safety, Pharmacokinetics, and Preliminary Efficacy of Riluzole in Patients with Traumatic Spinal Cord Injury. J Neurotrauma 2013 Oct 11. [Epub ahead of print] (Among 36 patients with acute spinal cord injury treated with riluzole twice daily for 14 days, ALT elevaitons occurred in 70%, but elevations were usually mild-to-moderate and resolved once therapy was stopped, no patient developing jaundice or progressive increase in values). 23859435
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to riluzole or other drugs for Alzheimer disease or amyotrophic lateral sclerosis). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to riluzole or drugs for Alzheimer disease). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 82 [9%] were attributed to central nervous system agents, but none to riluzole or drugs for Alzheimer disease). 25754159
Mathew SJ, Gueorguieva R, Brandt C, Fava M, Sanacora G. A randomized, double-Blind, placebo-controlled, sequential parallel comparison design trial of adjunctive riluzole for treatment-resistant major depressive disorder. Neuropsychopharmacology 2017; 42: 2567-74. (Among 104 adults with major depressive disorder treated with riluzole or placebo for 4 to 8 weeks, there was no change in depression assessment scores and adverse events included headache, fatigue and body pain, and no riluzole treated subject had ALT or AST values that rose to above 5 times ULN). 28553836

## OTHER REFERENCE LINKS

1. Recent References on Riluzole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Riluzole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Riluzole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Riluzole)